# Buprenorphine

## OVERVIEW

### Introduction

Buprenorphine is a sublingually and transdermally available, semisynthetic opioid analgesic, which is used as an analgesic and for management of opioid dependence. Therapy with buprenorphine is associated with mild and transient serum enzyme elevations, and with moderate-to-severe clinically apparent liver injury when abused by intravenous administration or the sublingual formations.

### Background

Buprenorphine (bue" pre nor' feen) is a semisynthetic opioid that is 25 to 50 times more potent than morphine and has been used as an analgesic as well as therapy of opioid addiction. Buprenorphine is a partial µ-opioid receptor agonist and a κ-receptor antagonist accounting for its benefit for opioid deterrence. Buprenorphine competes with morphine and heroin for the µ receptor, but is only a partial agonist and has a “ceiling” effect. Buprenorphine was approved for treatment of opioid addiction in 2004 and is a schedule III controlled substance. Current indications include treatment of moderate-to-severe pain (parenterally in low doses <1 mg) and opiate addiction (in various formulations in higher doses 2 to 16 mg daily). Buprenorphine is available as 2 and 8 mg tablets for sublingual administration generically and under the brand name Subutex, and in 1 mL ampules of 0.3 mg/mL for intravenous (iv) or intramuscular (im) injection generically and under the brand name Buprenex. More recently, buccal film formulations, transdermal patches (Butrans and generics), once monthly prolonged release injections (Sublocade) and once every 6 months implants injected subcutaneously (Probuphine) with buprenorphine have become available as therapy for opioid dependence. Buprenorphine is also available in fixed combination with naloxone (tablets and buccal films: 2 mg/0.5 mg and 8 mg/2 mg) for sublingual administration generically and under the brand name Suboxone. Naloxone is not absorbed orally, but provides full opioid antagonism if the combination is administer intravenously, as might occur with intentional abuse. Oral naloxone may also help to alleviate the gastrointestinal side effects of opioids such as constipation, nausea, vomiting and abdominal bloating. Finally, parenteral forms of buprenorphine are used for moderate-to-severe pain and administered iv or im, the typical dose being 0.3 mg every 6 hours as needed. Common side effects of buprenorphine include headache, dizziness, fatigue, sedation, dry mouth, urinary retention, diaphoresis, orthostatic hypotension, biliary spasm and withdrawal symptoms. Rare but potentially severe adverse reactions include life threatening respiratory and CNS depression, hepatotoxicity, adrenal insufficiency, interactions with other sedative medications, unintentional pediatric exposure and neonatal opioid withdrawal syndrome. Buprenorphine should be prescribed only by a health care provider with training in opioid dependency and managing the dosing and side effects of buprenorphine and naloxone.

### Hepatotoxicity

Buprenorphine therapy has been associated with a low rate of serum enzyme elevations during treatment, although the populations studied (opioid dependent) often have coexisting chronic liver diseases which complicate such assessments. Nevertheless, rates of ALT elevations during treatment with buprenorphine (with or without naloxone) have been minimally or no greater than with comparator arms (methadone).

In addition, there have been several reports and case series of acute, clinically apparent liver injury arising within 2 to 20 weeks of starting buprenorphine, usually (but not invariably) following misuse and intravenous administration of sublingual tablets. However, some cases occurred in patients who denied intravenous use and were on conventional sublingual doses. In most cases, the pattern of serum enzyme elevations was hepatocellular and the presentation resembled acute toxic hepatic necrosis. Immunoallergic features (fever, rash and eosinophilia) were not present, nor were autoantibodies detected. Almost all patients with this injury had concurrent chronic hepatitis C, and several appeared to resolve the chronic infection with the acute liver injury (Case 1). Strikingly, most patients were able to continue buprenorphine without recurrence, some of whom admitted to continued intravenous abuse.

Likelihood score: B[HD] (likely rare cause of clinically apparent liver injury usually associated with overdose or misuse).

### Mechanism of Injury

Buprenorphine undergoes extensive first pass hepatic extraction and is metabolized primarily by the cytochrome P450 system (CYP 3A4). The low doses used and rapid metabolism may account for its relative lack of hepatotoxicity when used in conventional doses. The appearance of an acute hepatic necrosis after intravenous injection of the sublingual tablets is likely due to direct toxicity of these high parenteral doses. The occurrence of this syndrome largely in patients with concurrent hepatitis C remains unexplained. Clearance of hepatitis C during this toxic injury raises the issue of whether the acute injury is actually due to an exacerbation of hepatitis C or whether the severe acute toxic injury can induce viral clearance.

### Outcome and Management

The severity of liver injury attributed to buprenorphine has ranged from mild-to-severe hepatitis, and fatal instances have been reported. Interestingly, most patients subsequently tolerated restarting buprenorphine at doses used prior to the toxic event, and some patients continued to misuse it by intravenous injection, but did not have recurrence of the liver injury.

Drug Class: Substance Abuse Treatment Agents; Opioids

## CASE REPORT

### Case 1. Acute liver injury attributed to buprenorphine use in a patient with chronic hepatitis C.(1)

A 33 year old male injection drug user with chronic hepatitis C (HCV genotype 1a) developed jaundice, abdominal pain and fever shortly after injecting 3 to 5 crushed and dissolved tablets of buprenorphine (8 mg, meant for sublingual administration) intravenously. He was known to have chronic hepatitis C, but had never been treated for the infection which was considered mild. He had no other history of liver disease but consumed alcohol regularly. He took no other medications. On admission, laboratory tests showed a serum bilirubin of 29.6 mg/dL with marked elevations in serum aminotransferase levels (ALT 4132 U/L, AST 3947 U/L) and mild increases in alkaline phosphatase (347 U/L) and GGT (127 U/L; normal <50) (Table). The prothrombin index was 43% of control (INR 1.7). A transjugular liver biopsy showed panlobular necrosis, diffuse lobular inflammation, and marked cholestasis indicative of acute hepatic injury. In addition, there was moderate portal fibrosis and portal inflammation suggestive of an underlying chronic hepatitis C. Tests for hepatitis A and B and HIV were negative. Anti-HCV was present, but serum HCV RNA was present at very low levels (15 IU/mL). Jaundice resolved within a week and serum enzymes fell rapidly. Sublingual buprenorphine was restarted without a change in the pattern of recovery. In follow up 3 months later, serum ALT levels were normal and HCV RNA was undetectable. When seen almost a year later, he admitted to continuing to self-inject buprenorphine, yet serum ALT levels were still normal and HCV RNA was undetectable.

#### Key Points

Medication: | Buprenorphine (24 mg intravenously)
Pattern: | Hepatocellular (R=31)
Severity: | 4+ (jaundice and prolongation of INR)
Latency: | Short, specific time not provided
Recovery: | Rapid, within 1-2 months
Other medications: | None

#### Laboratory Values

Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | 4132 | 347 | 29.6 | Admission
2 days | 2546 | 288 | 26.9 | Prothrombin time 18 sec
2 weeks | 132 | 80 | 2.2 | Buprenorphine restarted
4 months | Normal | | | HCV RNA negative
10 months | 11 | | | HCV RNA negative
Normal | <40 | <104 | <1.2

#### Comment

The clinical presentation of acute hepatic necrosis shortly after intravenous abuse of buprenorphine has been reported in several case reports and single center series of as many as 7 cases. Intriguingly, virtually all patients reported with this syndrome had a preexisting chronic hepatitis C, although many were HCV RNA negative at the time of the acute illness. The current case documents the loss of HCV RNA during the acute hepatic injury attributed to buprenorphine. Two explanations are possible. First, that the acute toxic hepatic injury caused an interruption in the replication of HCV or triggered host immune responses (the innate immune system and interferon production), resulting in clearance of hepatitis C. A second explanation is that the acute illness was due to an exacerbation of the chronic HCV infection, which led to an acute hepatitis C-like clearance of virus. The role of hepatitis C in this reaction is perhaps demonstrated best by the absence of recurrence of liver injury when buprenorphine was restarted and even when abused intravenously in high doses. The combination of buprenorphine with naloxone (a full µ opioid receptor antagonist) was developed to discourage such intravenous abuse.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Buprenorphine – Generic, Buprenex®, Subutex® (SL Tablets)

Buprenorphine/Naloxone – Generic, Suboxone®

DRUG CLASS

Substance Abuse Treatment Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Buprenorphine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Buprenorphine | 52485-79-7 | C29-H41-N-O4

## CITED REFERENCES

1 Peyrière H, Tatem L, Bories C, Pageaux GP, Blayac JP, Larrey D. (2009). Hepatitis after intravenous injection of sublingual buprenorphine in acute hepatitis C carriers: report of two cases of disappearance of viral replication after acute hepatitis. Ann Pharmacother.

## ANNOTATED BIBLIOGRAPHY

References updated: 24 November 2020

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of hepatotoxicity published in 1999 before the availability of buprenorphine).
Larrey D, Ripault M-P. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 443-62. (Review of hepatotoxicity of drugs of abuse mentions that hepatotoxicity from buprenorphine is rare when used in recommended sublingual doses, but that severe reactions occur when used by the intravenous route, possibly as a result of mitochondrial injury).
Yaksh T, Wallace M. Opioids, analgesia, and pain management. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 355-386. (Textbook of pharmacology and therapeutics).
Hirschauer C, Guillemot F, Héud M, Mathieu-Chandelier C, Cortot A, Paris JC. (1989). Gastroenterol Clin Biol. (36 year old man developed abnormal liver tests 3 months after starting buprenorphine for chronic pain [bilirubin 0.6 mg/dL, ALT 100 U/L, GGT 899 U/L], resolving rapidly, but rising again on rechallenge [ALT 52 U/L]; biopsy showed steatosis and inflammation, and the patient admitted to alcohol use [50 g/day]).
Houdret N, Asnar V, Szostak-Talbodec N, Leteurtre E, Humbert L, Lecomte-Houcke M, Lhermitte M, Paris JC. (1999). Acta Clin Belg. (33 year old man developed hepatic and renal failure 1-2 days after taking an overdose of buprenorphine [112 mg] [bilirubin 5.5 mg/dL, ALT 11,080 U/L, Alk P 334 U/L, prothrombin index 20%, creatinine 8.0 mg/dL], with subsequent rapid and complete recovery).
Berson A, Gervais A, Cazals D, Boyer N, Durand F, Bernuau J, Marcellin P, et al. (2001). Hepatitis after intravenous buprenorphine misuse in heroin addicts. J Hepatol. (Five cases of acute hepatitis-like injury in male heroin users, ages 25 to 34 years, arising after 2-8 weeks of buprenorphine therapy, 4 admitted to iv injection [bilirubin 0.8-11 mg/dL, ALT 520-6595 U/L, Alk P 126-306 U/L], one with hepatic failure, rapidly resolving, but all 5 had chronic hepatitis C, one had concurrent hepatitis B and one had HIV infection; several were continued on sublingual buprenorphine without recurrence).
Wisniewski B, Perlemuter G, Buffet C. (2001). Gastroenterol Clin Biol. (25 year old with chronic hepatitis C and heroin use developed jaundice 72 hours after injecting buprenorphine intravenously [bilirubin 4.3 mg/dL, ALT 31 times ULN, Alk P 2.5 times ULN, HCV RNA positive], biopsy showing acute hepatitis and cholestasis; rapid recovery).
Petitjean S, Stohler R, Deglon JJ, Livoti S, Waldvogel D, Uehlinger C, Ladewig D. (2001). Double-blind randomized trial of buprenorphine and methadone in opiate dependence. Drug Alcohol Depend. (Controlled trial comparing methadone to buprenorphine in 58 patients with opioid dependence found poorer retention rate with buprenorphine; no hepatotoxicity reported).
Vidal-Trecan G, Varescon I, Nabet N, Boissonnas A. (2003). Intravenous use of prescribed sublingual buprenorphine tablets by drug users receiving maintenance therapy in France. Drug Alcohol Depend. (Survey of 404 subjects on maintenance buprenorphine for opiate abuse found that 46% admitted to illicit intravenous self-administration).
Mattick RP, Ali R, White JM, O'Brien S, Wolk S, Danz C. (2003). Buprenorphine versus methadone maintenance therapy: a randomized double-blind trial with 405 opioid-dependent patients. Addiction. (Controlled trial in 405 patients with opioid dependence found similar rates of adverse events with buprenorphine and methadone; one patient had hepatitis C, but no other liver related adverse events reported).
Fudala PJ, Bridge TP, Herbert S, Williford WO, Chiang CN, Jones K, Collins J, et al. (2003). Buprenorphine/Naloxone Collaborative Study Group Office-based treatment of opiate addiction with a sublingual-tablet formulation of buprenorphine and naloxone. N Engl J Med. (Controlled trial of buprenorphine/naloxone vs buprenorphine alone vs placebo for 4 weeks in 326 opiate addicted patients; ALT elevations occurred in 10 patients, but 8 had concurrent hepatitis B or C).
Hervé S, Riachi G, Noblet C, Guillement N, Tanasescu S, Goria O, Thuillez C, et al. (2004). Acute hepatitis due to buprenorphine administration. Eur J Gastroenterol Hepatol. (7 cases of hepatotoxicity attributed to buprenorphine, all heroin addicts, 6 men and 1 woman, ages 24 to 38 years on buprenorphine [2-12 mg/day] for 4-20 weeks, sublingual in 6 and by injection in one, all had anti-HCV and 2 HCV RNA, 2 HBsAg [ALT 9 to 68 times ULN], 5 with jaundice [bilirubin levels not given]; all recovered rapidly despite continuing buprenorphine [at reduced doses in 3]).
Zuin M, Giorgini A, Selmi C, Battezzati PM, Cocchi CA, Crosignani A, Benetti A, et al. (2009). Acute liver and renal failure during treatment with buprenorphine at therapeutic dose. Dig Liver Dis. (33 year old man with chronic hepatitis C and heroin use developed jaundice 3 weeks after starting sublingual buprenorphine [20 mg daily] [bilirubin 8.4 mg/dL, ALT 300 times ULN, INR 3.1, creatinine 4.6, HCV RNA positivity], but rapid recovery and ALT levels normal and HCV RNA negative in follow-up).
Peyrière H, Tatem L, Bories C, Pageaux GP, Blayac JP, Larrey D. (2009). Hepatitis after intravenous injection of sublingual buprenorphine in acute hepatitis C carriers: report of two cases of disappearance of viral replication after acute hepatitis. Ann Pharmacother. (Two male injection drug users, 33 and 50 years old, with chronic hepatitis C presented with jaundice after injecting buprenorphine [bilirubin 29.6 and 2.1 mg/dL, ALT 4132 and 866 U/L, Alk P 347 and 1028 U/L], resolving rapidly and associated with loss of HCV RNA: Case 1).
Orman JS, Keating GM. (2009). Buprenorphine/naloxone: a review of its use in the treatment of opioid dependence. Drugs. (Review of the pharmacology, safety and efficacy of the combination of buprenorphine and naloxone as therapy of opioid dependence; no report of clinically apparent liver injury in preregistration clinical trials).
Pinto H, Maskrey V, Swift L, Rumball D, Wagle A, Holland R. (2010). The SUMMIT trial: a field comparison of buprenorphine versus methadone maintenance treatment. J Subst Abuse Treat. (Patient preference controlled trial comparing buprenorphine and methadone for up to 6 months in 361 opiate dependent subjects; no discussion of hepatotoxicity or ALT elevations).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none to buprenorphine or other agents used to treat substance abuse).
Vergara-Rodriguez P, Tozzi MJ, Botsko M, Nandi V, Altice F, Egan JE, O'Connor PG, et al. (2011). BHIVES Collaborative. Hepatic safety and lack of antiretroviral interactions with buprenorphine/naloxone in HIV-infected opioid-dependent patients. J Acquir Immune Defic Syndr. (Among 141 HIV infected subjects treated with buprenorphine/naloxone for 6 months, median serum ALT and AST values did not change and no patient developed clinically apparent liver injury, 3 had transient ALT elevations during treatment [383, 123 and 218 U/L], but all resolved either spontaneously or with drug discontinuation).
Dasgupta N, Bailey EJ, Cicero T, Inciardi J, Parrino M, Rosenblum A, Dart RC. (2010). Post-marketing surveillance of methadone and buprenorphine in the United States. Pain Med. (Between 2003 and 2007 there were increases in the rates of abuse and diversion of both methadone and buprenorphine in the US, the rates being higher for methadone).
Upadhyay A, Xueming Y. (2010). Buprenorphine-induced elevated liver enzymes in an adolescent patient. J Child Adolesc Psychopharmacol. (17 year old girl developed abdominal pain and enzyme elevations 9 days after starting buprenorphine with naloxone [bilirubin normal, ALT 452 U/L, anti-HCV negative], resolving rapidly on stopping; also taking quetiapine and tizanidine).
Bogenschutz MP, Abbott PJ, Kushner R, Tonigan JS, Woody GE. (2010). Effects of buprenorphine and hepatitis C on liver enzymes in adolescents and young adults. J Addict Med. (Among 152 patients with opioid dependence treated with 2 vs 12 weeks of buprenorphine with naloxone, ALT elevations occurred in 13% vs 23% of patients, but were mostly attributed to underlying HCV infection).
Kraus ML, Alford DP, Kotz MM, Levounis P, Mandell TW, Meyer M, Salsitz EA, et al. (2011). Statement of the American Society of Addiction Medicine Consensus Panel on the Use of Buprenorphine in Office-Based Treatment of Opioid Addiction. J Addict Med. (Guidelines and recommendations for use of buprenorphine in office based practice; no discussion of hepatotoxicity).
Steiner DJ, Sitar S, Wen W, Sawyerr G, Munera C, Ripa SR, Landau C. (2011). Efficacy and safety of the seven-day buprenorphine transdermal system in opioid-naïve patients with moderate to severe chronic low back pain: an enriched, randomized, double-blind, placebo-controlled study. J Pain Symptom Manage. (541 patients with severe low back pain were randomized to receive transdermal buprenorphine or placebo for 12 weeks; overall, clinical laboratory test results did not change on buprenorphine treatment).
Amass L, Pukeleviciene V, Subata E, Almeida AR, Pieri MC, D'Egidio P, Stankova Z, et al. (2012). A prospective, randomized, multicenter acceptability and safety study of direct buprenorphine/naloxone induction in heroin-dependent individuals. Addiction. (Among 187 injection drug users treated for 4 weeks with buprenorphine with naloxone, common side effects included insomnia, sweating, nausea and anxiety, but all serious adverse events were considered unrelated; no mention of ALT elevations).
Ray R, Vaswani M, Deb KS, Sethi H, Chopra A, Kishore N, Goyal R. (2012). Post marketing surveillance of sublingual buprenorphine naloxone combination tablets. Indian J Physiol Pharmacol. (Among 158 patients with opioid dependence treated with buprenorphine with naloxone, liver enzyme elevations were reported in 52% of patients, but none was associated with severe hepatitis).
Saxon AJ, Ling W, Hillhouse M, Thomas C, Hasson A, Ang A, Doraimani G, et al. (2013). Buprenorphine/Naloxone and methadone effects on laboratory indices of liver health: a randomized trial. Drug Alcohol Depend. (Among 731 patients with opioid dependency treated with either buprenorphine with naloxone or methadone for at least 24 weeks, 12.6% vs 17.9% developed ALT elevations [>2 times ULN], which were "extreme" in only 2.1% vs 3.6% [bilirubin 0.7-3.7 mg/dL, ALT 418-6280 U/L], usually attributable to underlying HBV or HCV infection, but specific details were not provided).
Soyka M, Backmund M, Schmidt P, Apelt S. (2014). Buprenorphine-naloxone treatment in opioid dependence and risk of liver enzyme elevation: results from a 12-month observational study. Am J Addict. (Among 188 opioid dependent patients treated with buprenorphine/naloxone for 12 months, 1-2% had liver enzyme elevations that were “mostly discrete” [all less than 100 U/L], transient and without jaundice or symptoms).
Lucas GM, Young A, Donnell D, Richardson P, Aramrattana A, Shao Y, Ruan Y, et al., HPTN 058 study group. (2014). Hepatotoxicity in a 52-week randomized trial of short-term versus long-term treatment with buprenorphine/naloxone in HIV-negative injection opioid users in China and Thailand. Drug Alcohol Depend. (Among 1036 patients with opioid use disorder treated with buprenorphine/naloxone in short [18 day] or long [52 week] courses, serum ALT elevations above 3 times ULN arose in 76 patients [7%], most instances occurring with either acute or chronic HCV infection and rates of ALT elevations were similar with either short and long term use, as well as after discontinuation of the medication).
Nasser AF, Heidbreder C, Liu Y, Fudala PJ. (2015). Pharmacokinetics of sublingual buprenorphine and naloxone in subjects with mild to severe hepatic impairment (Child-Pugh Classes A, B, and C), in hepatitis C virus-seropositive subjects, and in healthy volunteers. Clin Pharmacokinet. (Pharmacokinetic study of sublingual buprenorphine and naloxone in 33 patients with variable degrees of hepatic dysfunction identified higher plasma concentrations of both agents in patients with moderate or severe dysfunction (Child’s Pugh B and C], but not in those with mild dysfunction or chronic HCV infection without cirrhosis; side effects included dizziness, nausea, fatigue and pruritus but there were “no post-dose findings of clinical relevance in clinical laboratory” tests ).
French J, Mujumdar A, Angus P, Gow P. (2015). Fulminant hepatic failure after intravenous injection of sublingual buprenorphine in a patient with hepatitis C. Clin Case Rep. (20 year old indigenous Australian male with known chronic hepatitis C and injection drug abuse developed severe hepatitis with jaundice arising a day after injecting buprenorphine/naloxone meant for sublingual use [bilirubin 13.8 mg rising to 26.4 mg/dL, ALT 8768 U/L, INR 9, lactate 5.6 ], with rapid recovery with medical management, no follow up of HCV status after recovery).
Ciftci Demirci A, Gunes H, Adaletli H, Bulanik E, Erdogan A. (2015). Liver enzyme levels in adolescent patients treated with buprenorphine and additional psychotropic agents. Am J Drug Alcohol Abuse. (Among 59 heroin-dependent adolescents started on buprenorphine/naloxone, mean serum ALT and AST levels rose by week 2 but returned to baseline levels by week 8 of therapy; one patient developed acute hepatitis C during treatment).
Tetrault JM, Tate JP, Edelman EJ, Gordon AJ, Lo Re V, Lim JK, Rimland D, et al. (2016). Hepatic safety of buprenorphine in HIV-infected and uninfected patients with opioid use disorder: the role of HCV-infection. J Subst Abuse Treat. (Among 666 patients [mostly men] identified in a Veterans Administration electronic medical database who were started on buprenorphine and were monitored, 14 developed “drug-induced liver injury”, all of whom had received a potentially hepatotoxic medication [93%] or had preexisting HCV infection [7%], and there was no overall “substantial” change in serum ALT, AST or bilirubin levels).
Aldemir E, Coskunol H, Kilic M, Sert I. (2016). Treatment of opioid dependence with buprenorphine/naloxone after liver transplantation: Report of two cases. Transplant Proc. (Two patients with liver transplants for chronic hepatitis C and opioid use disorder were treated successfully with buprenorphine/naloxone with no significant side effects or worsening of minimal ALT and AST elevations due to recurrent hepatitis C ).
(2016). Buprenorphine implants (Probuphine) for opioid dependence. Med Lett Drugs Ther. (Concise summary of the mechanism of action, efficacy, safety and costs of a subdermally administered implant that provides plasma levels of buprenorphine for 6 months and appears to be similar in efficacy to transdermal or buccal administration, but has added adverse effects such as injury from the insertion and removal of the implant; mentions that hepatotoxicity has occurred with buprenorphine therapy).
(2016). Buprenorphine buccal film (Belbuca) for chronic pain. Med Lett Drugs Ther. (Concise summary of the mechanism of action, efficacy, safety and costs of a new formulation of buprenorphine provided as a buccal film).
Pergolizzi JV, Raffa RB, Marcum Z, Colucci S, Ripa SR. (2017). Safety of buprenorphine transdermal system in the management of pain in older adults. Postgrad Med. (Review of the literature on the safety and efficacy of buprenorphine in elderly patients mentions that liver abnormalities are rare [<1%] and ALT values above 3 times ULN occur in only 0.2% of both elderly and younger adults).
Concheiro M, Chesser R, Pardi J, Cooper G. (2018). Postmortem toxicology of new synthetic opioids. Front Pharmacol. (Summary of the chemical structures, pharmacology, relative potency and toxicology of the major synthetic opioids implicated in the ongoing opioid overdose epidemic; no discussion of hepatic injury).
Grebely J, Feld JJ, Wyles D, Sulkowski M, Ni L, Llewellyn J, Mir HM, et al. (2018). Sofosbuvir-based direct-acting antiviral therapies for HCV in people receiving opioid substitution therapy: an analysis of phase 3 studies. Open Forum Infect Dis. (Among 4743 patients enrolled in phase 3 trials of direct acting antiviral agents for HCV, 194 [4%] were on opioid substitution therapy including 75 on buprenorphine or buprenorphine/naloxone; the sustained virologic response rate was similar in those receiving buprenorphine [96%] to that in those who were not on any substitution therapy [97%] and adverse event rates were also similar).
(2018). Once-monthly subcutaneous buprenorphine (Sublocade) for opioid use disorder. Med Lett Drugs Ther. (Concise review of the mechanism of action, efficacy, safety and costs of a once-monthly formulation of buprenorphine given subcutaneously and providing plasma levels similar to those with sublingual buprenorphine, mentions that serum aminotransferase elevations are frequent with its use).

## OTHER REFERENCE LINKS

1 Recent References on Buprenorphine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Buprenorphine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Buprenorphine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Buprenorphine)